# Berotralstat

## OVERVIEW

### Introduction

Berotralstat is a small molecule inhibitor of plasma kallikrein that is used to prevent acute attacks of hereditary angioedema (HAE) in adults and children 12 years of age or older. Berotralstat has been linked to occasional mild-to-moderate elevations in serum aminotransferase levels during therapy but has not been implicated in instances of clinically apparent liver injury with symptoms or jaundice.

### Background

Berotralstat (ber” oh tral’ stat) is an orally available, small molecule inhibitor of plasma kallikrein used to prevent acute attacks of hereditary angioedema (HAE), an autosomal dominant condition marked by intermittent episodes of swelling and pain affecting multiple organs and tissues. HAE is caused by mutations in the SERPIN-G1 gene that encodes C1-esterase inhibitor, which is important in regulation of kallikrein and release of bradykinin. Elevated bradykinin levels cause an increase in vascular permeability resulting in the swelling and pain of acute attacks. Attacks commonly affect the gastrointestinal tract but may also involve the genitourinary tract, face, hands, feet, or skin. Potentially serious and even fatal attacks involve the larynx with laryngeal edema and airway compromise. In a registration randomized controlled trial, berotralstat therapy led to increases in serum C1-esterase inhibitor levels and a decrease in number and severity attacks of HAE. Berotralstat was approved in the United States in 2020 for prevention of acute attacks of HAE in adults and children 12 years of age or older, the first oral therapy for prophylaxis of attacks. Berotralstat is available in capsules of 150 and 110 mg under the brand name Orladeyo. The recommended initial dosage is 150 mg once daily with the lower dose of 110 mg daily for patients with possible drug-drug interactions, preexisting hepatic impairment, or gastrointestinal intolerance to treatment. In registration trials, the most frequent adverse events were abdominal pain, vomiting, diarrhea, back pain, and gastrointestinal reflux. Uncommon potentially severe adverse events include QTc prolongation.

Berotralstat should not be used to treat acute attacks of HAE. Several drugs are approved for therapy of acute attacks as well as for prevention of attacks in high risk individuals, but all require parenteral administration. These agents include human plasma derived preparations of C1-esterase inhibitor (Cinryze, Haegarda, Berinert), a recombinant human C1-esterase inhibitor (Ruconest), small protein inhibitors of plasma kallikrein (ecallantide, Kalbitor), a proteomimetic bradykinin B2 receptor blocker (icatibant, Firazyr), and a monoclonal antibody to kallikrein (lanadelumab, Takhzyro).

### Hepatotoxicity

In preregistration trials, mild, transient serum aminotransferase elevations occurred in 2% to 5% of patients receiving berotralstat vs 10% of those on placebo. Values above 5 times the upper limit of normal (ULN) were uncommon (less than 1%). Furthermore, bilirubin levels remained normal and no patient developed symptomatic acute liver injury. In many instances, other causes for the liver test abnormalities were present including preexisting nonalcoholic fatty liver disease, chronic viral hepatitis, or gallstone disease. Nevertheless, occasional patients required drug discontinuation because of liver test abnormalities. Since its licensure and more widescale clinical use, there have been no published reports of acute liver injury attributed to berotralstat.

Likelihood score: E* (unproven but suspected rare cause of clinically apparent liver injury).

### Mechanism of Injury

The causes of liver test abnormalities during berotralstat therapy of hereditary angioedema are often unrelated to the drug and are attributable to comorbidities, such as chronic viral hepatitis, gallstone disease, or malignancy. Nevertheless, berotralstat is metabolized in the liver, predominantly by CYP 2D6 and 3A4 and the hepatotoxicity or immunogenicity of a metabolite might be responsible for minor elevations in serum aminotransferase levels during therapy. In preregistration trials, liver test abnormalities were more frequent in patients with HAE who had been treated with androgenic steroids such as danazol in the recent past (typically stopping within the previous 2 weeks), a finding suggesting that the abnormalities related to the recent, precipitous withdrawal of the androgenic steroids.

### Outcome and Management

The product label for berotralstat does not recommend monitoring of routine liver tests during therapy, but testing patients before starting therapy is appropriate because of the frequency of comorbidities including liver disease in patients with HAE. A rise in serum aminotransferase levels during therapy should trigger evaluation for other possible causes. Persistence of unexplained ALT levels above 5 times the ULN or appearance of symptoms of liver injury or jaundice should lead to at least temporary discontinuation and more careful monitoring. Patients on chronic therapy with androgenic steroids for HAE should be gradually withdrawn from therapy and start treatment with berotralstat at least two weeks after stopping.

Drug Class: Genetic Disorder Agents, Hereditary Angioedema (HAE) Agents

Other Orally Active Drugs for Hereditary Angioedema: Danazol

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Berotralstat – Orladeyo®

DRUG CLASS

Genetic Disorder Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Berotralstat)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Berotralstat | 1809010-50-1 | C30-H26-F4-N6-O

## BIBLIOGRAPHY

References updated: 20 June 2024

Abbreviations: HAE, hereditary angioedema; ULN, upper limit of the normal range.

FDA. Integrated Review. 2020. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2020/214094Orig1s000MultidisciplineR.pdf (FDA Summary of the data on the safety and efficacy of berotralstat submitted in support of the application for approval as means of prevention of acute attacks of hereditary angioedema [HAE], mentions that ALT elevations were more frequent with placebo [10%] than berotralstat [2.4% to 5.1%], although one patient on the drug developed ALT elevations of above 5 times the upper limit of normal [ULN] and discontinued treatment with prompt resolution; no serious hepatic adverse events or liver injury with jaundice).
Aygören-Pürsün E, Bygum A, Grivcheva-Panovska V, Magerl M, Graff J, Steiner UC, Fain O, et al. Oral plasma kallikrein inhibitor for prophylaxis in hereditary angioedema. N Engl J Med. 2018;379:352-362. (Among 77 patients with HAE treated with berotralstat [62.5, 125, 250, or 350 mg] or placebo once daily for 28 days, acute HAE attacks were reduced by 47% to 75% by the higher doses, but adverse events also increased with dose including mild-to-moderate ALT elevations [but without symptoms or jaundice] of 7% and 11% at the two highest doses). 30044938
Lee A. Berotralstat: first approval. Drugs. 2021;81:405-409. (Summary of the mechanism of action, history of development, pharmacology, clinical efficacy, and safety of berotralstat shortly after its approval in the US as a means of prevention of attacks of HAE, does not mention ALT elevations or hepatotoxicity). 33646555
Zuraw B, Lumry WR, Johnston DT, Aygören-Pürsün E, Banerji A, Bernstein JA, Christiansen SC, et al. Oral once-daily berotralstat for the prevention of hereditary angioedema attacks: A randomized, double-blind, placebo-controlled phase 3 trial. J Allergy Clin Immunol. 2021;148:164-172.e9. (Among 120 patients with HAE [ages 23 years or older] treated with berotralstat [110 or 150 mg] or placebo once daily for 24 weeks, the acute attack rate was lower with berotralstat [1.7 and 1.3 vs 2.4 per month] while adverse events more frequent with drug included abdominal pain [10%-23% vs 10%], vomiting [10%-15% vs 3%], diarrhea [10%-15% vs 0%] and back pain [2%-10% vs 3%], and one patient on 150 mg daily developed an asymptomatic rise in ALT above 10 times ULN that resolved on discontinuation). 33098856
Wedner HJ, Aygören-Pürsün E, Bernstein J, Craig T, Gower R, Jacobs JS, Johnston DT, et al. Randomized trial of the efficacy and safety of berotralstat (BCX7353) as an oral prophylactic therapy for hereditary angioedema: results of APeX-2 through 48 weeks (Part 2). J Allergy Clin Immunol Pract. 2021;9:2305-2314.e4. (Among 108 patients with HAE participating in a 24-week controlled trial [Zuraw 2021] treated with open label berotralstat [110 or 150 mg daily] for another 24 weeks, the monthly acute attack rate continued to decline particularly with the higher dose, while adverse events were largely mild-to-moderate gastrointestinal complaints; no mention of ALT elevations or hepatotoxicity). 33866032
Berotralstat (Orladeyo) for prevention of hereditary angioedema. Med Lett Drugs Ther. 2021;63(1629):e7-e8. (Concise review of HAE, the mechanism of action of berotralstat, clinical efficacy, safety, and costs shortly after its approval in the US for prevention of acute attacks of HAE, mentions common adverse events of abdominal pain, vomiting, diarrhea, back pain, and reflux, and the possibility of prolongation of the QTc interval, but does not mention ALT elevations or hepatoxicity). 34544111
Ahuja M, Dorr A, Bode E, Boulton APR, Buckland M, Chee S, Dalley C, et al. Berotralstat for the prophylaxis of hereditary angioedema-real-world evidence data from the United Kingdom. Allergy. 2023;78:1380-1383. (Survey of 54 patients with HAE started on berotralstat in the UK found that numbers of average monthly acute attacks decreased from 12.9 to 4.5 by 6 months along with overall symptom severity scores, reported side effects included cramps, nausea, diarrhea, vomiting and headaches, but no discontinuations for side effects and no mention of liver related events). 36609839
Peter JG, Desai B, Tomita D, Collis P, Stobiecki M. Assessment of HAE prophylaxis transition from androgen therapy to berotralstat: A subset analysis of the APeX-S trial. World Allergy Organ J. 2023;16:100841. (Among 39 patients with HAE who discontinued androgen therapy within 60 days of starting berotralstat [150 mg daily], 7 developed ALT elevations [6 above 5 times ULN and 5 requiring discontinuation] all of whom had stopped androgens within 14 days of starting berotralstat). 38020288
Kiani-Alikhan S, Gower R, Craig T, Wedner HJ, Kinaciyan T, Aygören-Pürsün E, Banerji A, et al.; APeX-2 investigators. Once-daily oral berotralstat for long-term prophylaxis of hereditary angioedema: the open-label extension of the APeX-2 randomized trial. J Allergy Clin Immunol Pract. 2024;12:733-743.e10. (Among 81 patients with HAE treated in previous controlled trials who were continued on berotralstat [150 mg daily] for an additional 4 years, efficacy was maintained and 15% of patients had treatment related adverse events but none were serious; no mention of ALT elevations or hepatotoxicity). 38122865
Riedl MA, Soteres D, Sublett JW, Desai B, Tomita D, Collis P, Bernstein JA; APeX-S Study Investigators. Hereditary angioedema outcomes in US patients switched from injectable long-term prophylactic medication to oral berotralstat. Ann Allergy Asthma Immunol. 2024;132:505-511.e1. (Among 34 US patients with HAE who were switched from injectable long term prophylaxis to oral berotralstat monotherapy, the monthly attack rate was 0.29 to 0.58 while mild-to-moderate gastrointestinal adverse events occurred in 35%, but there were no serious adverse events and ALT elevations and hepatotoxicity were not mentioned). 38006972

## OTHER REFERENCE LINKS

Recent References on Berotralstat: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Berotralstat+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

Trials on Berotralstat: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Berotralstat)